# Tositumomab

## OVERVIEW

### Introduction

Tositumomab is the combination of a monoclonal antibody to CD20 and iodine-131 which is used to treat refractory, advanced non-Hodgkin lymphoma. Tositumomab has not been associated with significant serum enzyme elevations during therapy or to cases of idiosyncratic, clinically apparent liver injury. However, tositumomab has potent immunosuppressive activity and is probably capable of causing reactivation of hepatitis B in susceptible patients.

### Background

Tositumomab (toe si tue’ moe mab) is a monoclonal antibody to the cell surface antigen CD20 (also known as human B lymphocyte restricted differentiation antigen: Bp35) which is found on mature B cells as well as 90% of neoplastic B cell such as occur in non-Hodgkin lymphoma. Engagement of tositumomab with CD20 leads to cell lysis and depletion of circulating and tissue B cells for 6 to 8 months. Tositumomab is given in combination with iodine-131 radiolabeled tositumomab which provides additional antineoplastic activity. Tositumomab and tositumomab I-131 were approved for use in previously treated, resistant non-Hodgkin lymphoma in the United States in 2003. Because of declining use and the availability of other anti-CD20 monoclonal antibodies, however, tositumomab was discontinued by its sponsor in 2014. Tositumomab was previously available in liquid solution in single use vials of 35 and 225 mg (14 mg/mL) and as Iodine 131 tositumomab solutions of varying concentrations. Dosing required a 2 part dosimetric step followed 7 to 14 days later by a 2-part therapeutic step. Tositumomab was meant to be given only for a single course. Common side effects included infusion reactions, chills, fever, nausea, fatigue, anemia, thrombocytopenia, neutropenia and infections. Less common but potentially severe side effects included severe allergic reactions, anaphylaxis, marked bone marrow suppression, thyroid abnormalities and radiation exposure.

### Hepatotoxicity

Serum aminotransferase elevations are uncommon during tositumomab therapy and rarely mentioned in large clinical trials of its use in non-Hodgkin lymphoma. Clinically apparent liver injury has not been reported with tositumomab therapy either in prelicensure clinical trials or subsequent to its general clinical use.

On the other hand, other monoclonal antibodies to CD20 such as rituximab and ofatumumab are well known to cause reactivation of hepatitis B. Specific features of the reactivation caused by tositumomab have not been published, but HBV reactivation is typically associated with acute hepatocellular injury that can be severe and lead to acute liver failure and death or need for emergency liver transplantation. Reactivation typically occurs in patients who are HBsAg carriers with inactive hepatitis B who undergo chemotherapy for cancer. Reactivation can also occur in persons who have recovered from hepatitis B, who have no detectable HBsAg, but have antibody to hepatitis B core antigen (anti-HBc) with or without antibody to HBsAg (anti-HBs) in serum. The usual sequence of events is appearance of rising levels of HBV DNA in serum shortly after chemotherapy is started followed by rise in levels of HBsAg and HBeAg. When therapy is stopped and immune reconstitution has begun, serum ALT and AST levels rise, which is followed by symptoms and jaundice. The onset of liver injury is delayed and may occur months after 3 to 6 courses of therapy. Reactivation of hepatitis B tends to be severe and the mortality rate in jaundiced cases exceeds 10%. Liver histology demonstrates an acute hepatitis like pattern with focal or confluent necrosis and prominent lymphocytic infiltrates of activated T cells, which is compatible with an immune mediated hepatic injury. Restarting chemotherapy can result in recurrence of injury, although concurrent antiviral treatment may block recurrence. Many cases of hepatitis B reactivation have been reported with rituximab therapy; the occurrence with tositumomab has been implied but specific cases have not been published.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury and possibly reactivation of hepatitis B).

### Mechanism of Injury

The mechanism of liver injury in reactivation of hepatitis B appears to be a brisk immunological response to newly expressed viral antigens on hepatocytes. Injury generally arises after immunosuppressive or cancer chemotherapy has stopped or between courses of treatment.

### Outcome and Management

Guidelines for management of patients who are to receive tositumomab recommend routine screening for hepatitis B before starting treatment. Screening should include tests for HBsAg and anti-HBc (and perhaps also anti-HBs as this may help in management). Prophylaxis with a potent oral, antiviral agent effective against hepatitis B is recommended for all persons who have HBsAg in serum and is suggested for those with anti-HBc without HBsAg. An alternative approach is careful monitoring for HBV DNA during therapy and early institution of antiviral therapy if levels rise.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tositumomab – Bexxar®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Tositumomab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tositumomab | 208921-02-2 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2020

Abbreviations: TNF, tumor necrosis factor.

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the tumor necrosis factor [TNF] alpha antagonists"; no specific discussion of tositumomab).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Vose JM, Wahl RL, Saleh M, Rohatiner AZ, Knox SJ, Radford JA, Zelenetz AD, et al. (2000). Multicenter phase II study of iodine-131 tositumomab for chemotherapy-relapsed/refractory low-grade and transformed low-grade B-cell non-Hodgkin's lymphomas. J Clin Oncol. (Among 47 patients with chemotherapy relapsed non-Hodgkin lymphoma treated with iodine-131 labelled tositumomab, clinical responses occurred in 57% and side effects included fatigue [41%], nausea [38%], fever [34%], infections, rash and fatigue; no mention of ALT elevations or hepatotoxicity).
Kaminski MS, Zelenetz AD, Press OW, Saleh M, Leonard J, Fehrenbacher L, Lister TA, et al. (2001). Pivotal study of iodine I 131 tositumomab for chemotherapy-refractory low-grade or transformed low-grade B-cell non-Hodgkin's lymphomas. J Clin Oncol. (Among 60 patients with previously treated non-Hodgkin lymphoma treated with iodine-I 131 labelled tositumomab, 65% had a partial or complete response; adverse events included fatigue, fever, nausea, pruritus, poor appetite and hypotension; no mention of ALT elevations or hepatotoxicity).
Rutar FJ, Augustine SC, Kaminski MS, Wahl RL, Siegel JA, Colcher D. (2001). Feasibility and safety of outpatient Bexxar therapy (tositumomab and iodine I 131 tositumomab) for non-Hodgkin's lymphoma based on radiation doses to family members. Clin Lymphoma. (Analysis of radiation doses of family members of recipients of iodine I-131 labelled tositumomab).
(2003). Iodine-131 tositumomab (Bexxar) for treatment of lymphoma. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of tositumomab shortly after its approval in the US; most patients develop neutropenia, thrombocytopenia and anemia and half have an infectious complications, 8% requiring hospitalization; no mention of hepatotoxicity or ALT elevations).
Davies AJ, Rohatiner AZ, Howell S, Britton KE, Owens SE, Micallef IN, Deakin DP, et al. (2004). Tositumomab and iodine I 131 tositumomab for recurrent indolent and transformed B-cell non-Hodgkin's lymphoma. J Clin Oncol. (Among 41 patients with non-Hodgkin lymphoma treated with tositumomab, response rates were 76% and toxicity was principally hematologic; no mention of ALT elevations or hepatotoxicity).
Kaminski MS, Radford JA, Gregory SA, Leonard JP, Knox SJ, Kroll S, Wahl RL. (2005). Re-treatment with I-131 tositumomab in patients with non-Hodgkin's lymphoma who had previously responded to I-131 tositumomab. J Clin Oncol. (Among 32 patients with advanced non-Hodgkin lymphoma who were retreated with tositumomab, 18 had a complete or partial response and adverse events were similar to those during the initial therapy although 5 patients developed a myelodysplastic syndrome 8-62 months after initial therapy; no mention of ALT elevations or hepatotoxicity).
Kaminski MS, Tuck M, Estes J, Kolstad A, Ross CW, Zasadny K, Regan D, et al. (2005). 131I-tositumomab therapy as initial treatment for follicular lymphoma. N Engl J Med. (Among 76 patients with advanced follicular B-cell lymphoma treated with tositumomab, 75% had a complete response and toxicity was common, but usually mild-to-moderate, hematologic adverse events being most common; no mention of ALT elevations or hepatotoxicity).
Witzig TE, Fishkin P, Gordon LI, Gregory SA, Jacobs S, Macklis R, McLaughlin P, et al. (2011). Treatment recommendations for radioimmunotherapy in follicular lymphoma: a consensus conference report. Leuk Lymphoma. (Consensus statement on use of radioimmunotherapy for follicular lymphoma; no mention of hepatotoxicity).
Press OW, Unger JM, Rimsza LM, Friedberg JW, LeBlanc M, Czuczman MS, Kaminski M, et al. (2013). Phase III randomized intergroup trial of CHOP plus rituximab compared with CHOP chemotherapy plus (131) iodine-tositumomab for previously untreated follicular non-Hodgkin lymphoma: SWOG S0016. J Clin Oncol. (Among 496 patients with previously untreated non-Hodgkin lymphoma who were treated with CHOP and either rituximab or I-131 tositumomab, objective responses [94% vs 84% ] and both progression free and overall survival [92% vs 86% at 5 years] were similar in the two groups, as were adverse events including secondary malignancies [8% vs 9%]; no mention of ALT elevations or hepatotoxicity).
Mitka M. (2013). FDA: Increased HBV reactivation risk with ofatumumab or rituximab. JAMA. (News report of the FDA alert to physicians of the high risk of HBV reactivation in patients receiving ofatumumab or rituximab, two monoclonal antibodies to CD20).
Goldsmith SJ. (2020). Targeted radionuclide therapy: A historical and personal review. Semin Nucl Med. (Review of the history of development of radionuclide therapy using monoclonal antibodies to target the radioactivity including tositumomab, which was withdrawn by its sponsor for economic rather than scientific or safety issues).
Sachpekidis C, Jackson DB, Soldatos TG. (2019). Radioimmunotherapy in non-Hodgkin's lymphoma: retrospective adverse event profiling of Zevalin and Bexxar. Pharmaceuticals (Basel). (Review of adverse event reports made to the FDA and WHO for tositumomab demonstrated an increase after 2003 to a peak in 2005 and subsequent gradual decrease, correlating with change in usage; most common adverse events were myelodysplastic syndrome, fever, acute myeloid leukemia, fatigue and nausea; liver injury and ALT elevations were not mentioned).
Shadman M, Li H, Rimsza L, Leonard JP, Kaminski MS, Braziel RM, Spier CM, et al. (2018). Continued excellent outcomes in previously untreated patients with follicular lymphoma after treatment with CHOP plus rituximab or CHOP plus (131)I-tositumomab: long-term follow-up of phase III randomized study SWOG-S0016. J Clin Oncol. (Long term follow up of trial comparing R-CHOP to CHOP with tositumomab [Press 2013] found radiotherapy resulted in better progression-free survival but similar overall survival, the occurrence of deaths from leukemia and myelodysplastic syndrome with radiation exposure being greater; no mention of hepatotoxicity or liver related deaths).
Hadid T, Raufi A, Kafri Z, Mandziara M, Kalabat J, Szpunar S, Kolizeras K, et al. (2016). Safety and efficacy of radioimmunotherapy (RIT) in treatment of non-Hodgkin's lymphoma in the community setting. Nucl Med Biol. (Among 48 patients with refractory or relapsed malignant non-Hodgkin lymphoma treated at a community center with tositumomab, overall median survival was 48 months and the major toxicities were hematologic; no mention of ALT elevations or hepatotoxicity).
Leonard JP, Gregory SA, Smith H, Horner TJ, Williams VC, Giampietro P, Lin TS. (2016). CHOP chemotherapy followed by tositumomab and Iodine-131 tositumomab for previously untreated diffuse large B-cell lymphoma. Clin Lymphoma Myeloma Leuk. (Among 15 patients with non-Hodgkin lymphoma treated with tositumomab after completing 6 cycles of CHOP, the response rate increased from 60% to 80% and adverse events included bone marrow suppression as well as fatigue [72%], dyspnea, headache and pain; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Tositumomab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tositumomab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tositumomab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tositumomab)